# Clozapine

## OVERVIEW

### Introduction

Clozapine was the first atypical antipsychotic approved for treatment of schizophrenia. Because it is associated with severe and potentially fatal side effects (agranulocytosis), its use is restricted to refractory schizophrenia, and monitoring during therapy is required. Clozapine therapy is associated with serum aminotransferase elevations and in rare instances has been linked to clinically apparent acute liver injury.

### Background

Clozapine (kloe" za peen) is an atypical antipsychotic medication that appears to act both as a dopamine (D) and serotonin (5-HT2) receptor antagonist. Clozapine was introduced into clinical practice in 1971, but subsequently withdrawn in 1975 after reports of fatal agranulocytosis with its use. Nevertheless, because of its potent activity, clozapine was approved for restricted use in refractory schizophrenia in the United States in 1989 and only with surveillance using close monitoring of complete blood counts. As a result, use of clozapine has been limited. Clozapine was also approved to prevent suicide in patients with schizophrenia or schizoaffective disorder. Clozapine is available as scored tablets of 25 and 100 mg in generic forms and under the brand names of Clozaril. The dosage of clozapine varies greatly. The starting dose is 12.5 mg once or twice daily, which can be cautiously increased to target doses of 300 to 450 mg daily clinical response and tolerability. Common side effects include sedation, tremors, drooling, dizziness, headache, hypotension and syncope, dry mouth, constipation, and weight gain. Uncommon, but potential severe side effects include severe neutropenia, agranulocytosis, orthostatic hypotension and syncope, falls, seizures, cardiomyopathy, prolongation of the QTc interval, diabetes, dyslipidemia, weight gain and neuroleptic malignant syndrome. Clozapine has a boxed warning of severe neutropenia orthostatic hypotension, bradycardia and syncope, seizure, myocarditis and cardiomyopathy and increased mortality in elderly patients with dementia-related psychosis. It is available only as a part of a Risk Evaluation and Mitigation Strategy (REMS) program that includes certification of healthcare providers and pharmacies, patient consent, and scheduled regular monitoring and reporting of neutrophil counts.

### Hepatotoxicity

Serum enzyme elevations arise in up to two-thirds of patients on clozapine but are usually modest and resolve spontaneously after 6 to 12 weeks, often not requiring dose modification or discontinuation. ALT elevations above 3 times ULN arise in 10% to 20% of patients but are usually transient. Occasionally, serum enzyme elevations are associated with symptoms of nausea, weakness and abdominal discomfort, and therapy should be discontinued or managed with careful dose reduction.

Acute, clinically apparent episodes of liver injury with marked liver enzyme elevations and jaundice have been reported in more than fifty patients receiving clozapine and is estimated to occur in ~1:2000 treated patients. The onset of injury is usually within a few days to several weeks after starting, and the pattern of serum enzyme elevations is typically mixed but can be hepatocellular or cholestatic. Severe instances of acute liver injury with progressive hepatic failure and death or need for emergency transplantation have been described usually occurring after a delay in stopping clozapine after onset of evidence of liver injury. Eosinophilia or leukocytosis occur in a proportion of patients, and Drug Reaction with Eosinophilia and Systemic Symptoms (DRESS) syndrome with fever and rash have been reported, although generally mild-to-moderate in severity and self-limited in course. Autoimmune markers are rare. Almost all cases resolve once therapy is stopped, vanishing bile duct syndrome and chronic injury have not been reported.

Likelihood score: A (a rare, but well-known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which clozapine causes liver injury is not known. Cases with features of hypersensitivity suggest that the injury is immunologically mediated. Clozapine is extensively metabolized by the liver, partially via the cytochrome P450 system (CYP 1A2 and others), and production of a toxic or immunogenic intermediate of metabolism may underlie the acute liver injury that can occur on clozapine therapy. Serum enzyme elevations during clozapine therapy can occasionally be managed with dose reduction, suggesting an element of direct hepatotoxicity.

### Outcome and Management

The serum aminotransferase elevations that occur on clozapine therapy are often self-limited and usually do not require dose modification or discontinuation of therapy. Most instances of clinically apparent liver injury due to clozapine have been mild-to-moderate in severity and rapidly resolve. Several cases of acute liver failure due to clozapine have been reported, but there have been no instances of chronic liver disease or vanishing bile duct syndrome. Re-exposure is usually followed by reoccurrence of injury with a more rapid time to onset. However, in several instances very cautious reintroduction with a slow escalation of dose has been tolerated without recurrence of liver injury. Persons with intolerance to clozapine can usually tolerate other atypical antipsychotic agents, such as haloperidol, risperidone, quetiapine and olanzapine.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clozapine – Generic, Clozaril®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Clozapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clozapine | 5786-21-0 | C18-H19-Cl-N4

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2023

Abbreviations: DRESS, drug reaction with eosinophilia and systemic symptoms.

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychiatric agents mentions that clozapine often causes mild to moderate ALT elevations but that “...clinically significant hepatotoxicity is uncommon”).
Brodowski L, Matusewicz W, Urbańska-Ryś H, Krykowski E. (1984). Pol Tyg Lek. (25 year old man developed jaundice and bone marrow failure 5 weeks after starting clozapine [bilirubin 5.7 mg/dL, ALT 268 U/L], with ultimate recovery upon stopping).
Schmidt G, Borsch G, Muller K-M, Ricken D. (1987). Dtsch med Wschr. (54 year old woman developed jaundice after 2 days of clozapine therapy [bilirubin 4.65 mg/dL, ALT 178 U/L, Alk P 239 U/L]; rapid recovery, and recurrence of ALT [82 U/L] and Alk P [328 U/L] elevations with rechallenge).
Naber D, Leppig M, Grohmann R, Hippius H. (1989). Efficacy and adverse effects of clozapine in the treatment of schizophrenia and tardive dyskinesia – a retrospective study of 387 patients. Psychopharmacology. (Retrospective analysis of 387 inpatients with resistant schizophrenia receiving clozapine for an average of 49 days between 1978-88; liver enzymes were elevated in 8% of patients, but rarely required discontinuation [0.5%]).
Dorta G, Siebenmann R, Frohli P, Freytag P, Koelz HR. (1989). Clozapin-induzierter cholestatistcher Ikterus: Ein Fallbericht. Z Gastroenterol. (65 year old woman developed fever followed by jaundice 10 days after starting clozapine [bilirubin 3.7 mg/dL, ALT 105 U/L, Alk P 902 U/L], but no rash or eosinophilia and resolution within 4 weeks of stopping).
Gaertner HJ, Fischer E, Hoss J. (1989). Side effects of clozapine. Psychopharmacology (Berl). (Retrospective analysis of 315 inpatients given clozapine; rise in serum enzymes in 61% of patients, >twice normal in 31%, absolute rise of 1 to 465 U/L; but no mention of jaundice or hepatitis).
Baldessarini RJ, Frankenburg FR. (1991). Clozapine. A novel antipsychotic agent. N Engl J Med. (Clozapine, the first atypical antipsychotic was introduced into use in US in 1990 with requirement for routine monitoring of blood counts; review of structure, mechanisms of action, metabolism, pharmacokinetics, efficacy, and side effects; no mention of hepatotoxicity or ALT elevations).
Kellner M, Wiedemann K, Krieg JC, Berg PA. (1993). Toxic hepatitis by clozapine treatment. Am J Psychiatry. (44 year old woman developed ALT elevations [675 U/L] during 5th week of clozapine therapy with normal Alk P and bilirubin, 28% eosinophils, resolving within 5 weeks of stopping, negative lymphocyte transformation tests).
Eggert AE, Crismon ML, Dorson PG, Taylor RL. (1994). Clozapine rechallenge after marked liver enzyme elevation. J Clin Psychopharmacol. (40 year old man developed liver enzyme elevations 6 weeks after starting clozapine [bilirubin 0.6 mg/dL, ALT 594 U/L, Alk P167 U/L], without symptoms and resolving within 4 weeks of stopping; rechallenge led to minor, transient ALT elevations falling to normal on long term use [>1 year]).
Marinkovic D, Timotijevic I, Babinski T, Totic S, Paunovic VR. (1994). The side-effects of clozapine: a four-year follow-up study. Prog Neuropsychopharmacol Biol Psychiatry. (Among 100 hospitalized patients on clozapine for up to 4 years, 36% developed liver enzyme elevations usually within 4-6 weeks, all responding to a dose reduction).
Hovens JE, Vogtländer LM, Verhoeve HA, Thunnissen PL. (1994). Ned Tijdschr Geneeskd. (38 year old woman developed malaise 1 week after starting clozapine [ALT rising to 444 U/L, Alk P 297 U/L, bilirubin 1.2 mg/dL], resolving within 1 month of stopping).
Thatcher GW, Cates M, Bair B. (1995). Clozapine-induced toxic hepatitis. Am J Psychiatry. (35 year old man developed fatigue, abdominal pain, rash, and fever 25 days after starting clozapine [bilirubin 2.2 mg/dL, ALT 719 U/L, GGT 70 U/L, eosinophils 7%], resolving within 5 weeks of stopping).
Worrall R, Wilson A, Gullen M. (1995). Dystonia and drug-induced hepatitis in a patient treated with clozapine. Am J Psychiatry. (30 year old woman with chronic hepatitis C had a rise in ALT from 67 to 424 U/L after 14 days of clozapine; ALT fell to normal [33 U/L] with lowering dose, but rose again [371 U/L] with subsequent dose escalation).
Hummer M, Kurz M, Kurzthaler I, Oberbauer H, Miller C, Fleischhacker WW. (1997). Hepatotoxicity of clozapine. J Clin Psychopharmacol. (Weekly liver tests during haloperidol [n=71] or clozapine [n=167] therapy identified ALT elevations in 46% and 67% of patients which were >twice normal in 17% and 37%; Alk P elevations occurred in 14% vs 41% but were never >twice normal; elevations usually appeared after 1-6 weeks of treatment and resolved even without dose modification).
Macfarlane B, Davies S, Mannan K, Sarsam R, Pariente D, Dooley J. (1997). Fatal acute fulminant liver failure due to clozapine: a case report and review of clozapine-induced hepatotoxicity. Gastroenterology. (39 year old man developed nausea, abdominal pain, and jaundice after 8 weeks of clozapine therapy [bilirubin 14.7 mg/dL, ALT 1375 U/L, Alk P 290 U/L]; delay in stopping clozapine with subsequent worsening, ascites, coma and death).
Markowitz JS, Grinberg R, Jackson C. (1997). Marked liver enzyme elevations with clozapine. J Clin Psychopharmacol. (27 year old man developed rising ALT after 4 weeks of clozapine therapy [bilirubin 1.2 mg/dL, ALT 1325 U/L, Alk P 144 U/L] without symptoms; values normalized within 3 weeks of stopping).
Wirshing WC, Ames D, Bisheff S, Pierre JM, Mendoza A, Sun A. (1997). Hepatic encephalopathy associated with combined clozapine and divalproex sodium treatment. J Clin Psychopharmacol. (37 year old woman developed jaundice and sedation followed by ascites and encephalopathy 6 weeks after starting combination of valproate and clozapine [bilirubin 2.8 mg/dL, ALT 1525 U/L, high valproate levels], responding slowly to drug withdrawal; restarting clozapine was later tolerated without liver abnormalities).
Young CR, Bowers MB, Mazure CM. (1998). Management of the adverse effects of clozapine. Schizophr Bull. (Clozapine is highly effective in schizophrenia but has a high rate of adverse side effects, requiring discontinuation in 17%; liver enzyme elevations of >twice baseline values reported in 31% of patients, but usually mild and resolve even with continuing treatment).
Thompson J, Chengappa KNR, Good CB, Baker RW, Kiewe RP, Bezner J, Schooler NR. (1998). Hepatitis, hyperglycemia, pleural effusion, eosinophilia, hematuria, and proteinuria occurring early in clozapine treatment. Int Clin Psychopharmacol. (48 year old man developed jaundice 2 weeks after starting clozapine [bilirubin 8.7 mg/dL, ALT 100 U/L, Alk P 257 U/L], resolving within 4 weeks of switching to risperidone).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, quetiapine +2.5, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg).
Jang SJ, Yi HT, Paek HJ, Lee SY. (1999). Clozapine-induced acute hepatitis. J Korean Neuropsychiatr Assoc.
Panagiotis B. (1999). Grand mal seizures with liver toxicity in a case of clozapine treatment. J Neuropsychiatry Clin Neurosci. (30 year old man had a seizure after 4 weeks of clozapine therapy and found to have elevations in previously normal ALT [215 U/L] and Alk P [318 U/L] levels; drug stopped but time to resolution, bilirubin levels and symptoms not reported).
Blum MW, Siegel AM, Meier R, Hess K. (2001). Neuroleptic malignant-like syndrome and acute hepatitis during tolcapone and clozapine medication. Eur Neurol. (70 year old woman given tolcapone and clozapine developed fever and stupor [ALT 71 rising to 988 U/L, CPK 531 rising to 3132 U/L, no mention of bilirubin], resolving within 10 days of stopping tolcapone, clozapine continued).
Larsen JT, Clemensen SV, Klitgaard NA, Nielsen B, Brøsen K. (2001). Ugeskr Laeger. (49 year old woman developed fever, eosinophilia, and hepatitis on 300 mg of clozapine and with high serum ALT levels; tolerated lower doses with serum monitoring; Abstract only).
Gaertner I, Altendorf K, Batra A, Gaertner HJ. (2001). Relevance of liver enzyme elevations with four different neuroleptics: a retrospective review of 7,263 treatment courses. J Clin Psychopharmacol. (Retrospective review of 233 inpatients between 1980-92; an increase in ALT in 78% of patients on clozapine and 50% on haloperidol; 3-fold increase in ALT in 15% with clozapine and 2.4% with haloperidol; lower rates of 2-fold alkaline phosphatase elevations [1% and 0.8%]).
Dumortier G, Cabaret W, Stamatiadis L, Saba G, Benadhira R, Rocamora JF, Aubriot-Delmas B, et al. (2002). Encephale. (Review of reports of liver injury due to atypical antipsychotics).
Mouradian-Stamatiadis L, Dumortier G, Januel D, Delmas BA, Cabaret W. (2002). Liver function tests during treatment with antipsychotic drugs: a case series of 23 patients. Prog Neuropsychopharmacol Biol Psychiatry. (Among 23 hospitalized patients on atypical antipsychotics, 6 had ALT or AST elevations by day 14 [ALT 48-158 U/L]; 2 were on risperidone, 2 olanzapine, 1 amisulpride, none clozapine; 1 on risperidone required stopping).
(2003). Choice of an antipsychotic. Med Lett Drugs Ther. (“Clozapine is usually reserved for treatment of patients refractory to other drugs because it causes granulocytopenia” in ~1% of patients; marked sedation and weight gain are also common; no mention of hepatotoxicity).
Kelly DL, Conley RR, Richardson CM, Tamminga CA, Carpenter WT. (2003). Adverse effects and laboratory parameters of high-dose olanzapine vs. clozapine in treatment-resistant schizophrenia. Ann Clin Psychiatry. (Comparison of high doses of olanzapine vs clozapine in 8-week crossover study in 13 patients; ALT elevations in 66% of clozapine-, but in no olanzapine-treated patients; weight gain greater with olanzapine [~3.4 kg] than clozapine [~1.4 kg]).
Prior TI, Baker GB. (2003). Interactions between the cytochrome P450 system and the second-generation antipsychotics. J Psychiatry Neurosci. (Review of the interactions of the atypical antipsychotics with the P450 system; clozapine metabolized by CYP1A2 and 3A4 and possibly 2C9 and 2D6; risperidone by CYP2D6 and possibly 3A4; olanzapine by CYP1A2 and possibly 2D6; quetiapine and ziprasidone by CYP3A4).
Bender S, Grohmann R, Engel RR, Degner D, Dittmann-Balcar A, Ruther E. (2004). Severe adverse drug reactions in psychiatric inpatients treated with neuroleptics. Pharmacopsychiatry. (Summary of severe adverse drug reactions reported among 35,293 inpatients; more common with atypicals [0.5-0.9%] than typical antipsychotic agents [0.02-0.2%], increased liver enzymes were the most common adverse reaction to olanzapine, 4th in frequency to clozapine, 6th to haloperidol, 7th to risperidone; no mention of hepatitis or acute liver failure).
Bell C, Delisle M. (2004). Can J Psychiatry. (46 year old woman gained 35 kg after 2 years of clozapine therapy and had ALT 100 U/L, but normal bilirubin with fatty liver on ultrasound; stopping therapy led to slow improvement in ALT; reintroduction at lower dose was tolerated without ALT elevations).
Erdogan A, Kocabasoglu N, Yalug I, Ozbay G, Senturk H. (2004). Management of marked liver enzyme increase during clozapine treatment: a case report and review of the literature. Int J Psychiatry Med. (27 year old man developed rise in ALT [151 U/L] without bilirubin or Alk P elevations after 2 weeks of clozapine therapy, resolved in 10 days of stopping; rechallenge led to rise in ALT to 208 U/L, biopsy showed minimal changes and lowering dose followed by improvements in ALT, allowing long term therapy).
Fong SY, Au Yeung KL, Tosh JM, Wing YK. (2005). Clozapine-induced toxic hepatitis with skin rash. J Psychopharmacol. (55 year old woman with onset of rash and fever 4 weeks after starting clozapine [bilirubin 1.3 mg/dL, ALT 595 U/L, Alk P 160 U/L, eosinophils rising from 3% to 31%], resolving within 1 month of stopping).
Rettenbacher MA, Baumgartner S, Eder-Ischia U, Edlinger M, Graziadei I, Hofer A, Huber R, et al. (2006). Association between antipsychotic-induced elevation of liver enzymes and weight gain: a prospective study. J Clin Psychopharmacol. (Prospective study of 67 patients started on atypical antipsychotics [3 on clozapine]; ALT elevations were more frequent in 14 patients who gained >7% of body weight than in the 53 who did not [50% vs 19%] and mean changes in ALT, AST and GGT were greater; all were transient, asymptomatic, and not associated with bilirubin elevations).
Freund N. [Psychiatric patient with elevated liver values]. Praxis (Bern 1994) 2006; 95: 549-50. (Case report of patient on clozapine who developed cholestatic liver injury 2 weeks after a course of amoxicillin/clavulanate).
Luo D, McColl P, Walmsley R. (2007). Acute onset of ascites with clozapine-induced hepatitis. Intern Med J. (43 year old woman developed fever 2 weeks after starting clozapine, eventually with abdominal pain, [bilirubin 0.6 mg/dL, ALT 246 U/L, Alk P 132 U/L, eosinophilia], worsening on continuing clozapine with pleural effusion and ascites, resolving with stopping drug).
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. (2008). Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; not with aripiprazole, ziprasidone, carbamazepine or lamotrigine).
Flanagan RJ. (2008). Side effects of clozapine and some other psychoactive drugs. Curr Drug Saf. (Thorough review of multitude of side effects of clozapine; ALT elevations occur in 30-50% of patients, usually resolving after 6-12 weeks; jaundice reported in 84 of 136,000 [0.06%] and fulminant hepatitis in 0.001%; 2 cases).
Gareri P, De Fazio P, Russo E, Marigliano N, De Fazio S, De Sarto G. (2008). The safety of clozapine in the elderly. Expert Opin Drug Saf. (Review on safety of clozapine; agranulocytosis occurred in 17 of 2260 patients [0.7%] in Finland; 50% fatality rate; ALT elevations in up to 10% of patients).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, severe antidepressants [duloxetine, sertraline, fluoxetine, amitriptyline], but none of the atypical antipsychotic agents were implicated).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo-controlled trials [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, +0.6 risperidone, -0.3 ziprasidone. A 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects).
Sacchetti E, Galluzzo A, Valsecchi P, Romeo F, Gorini B, Warrington L, MOZART Study Group. (2009). Ziprasidone vs clozapine in schizophrenia patients refractory to multiple antipsychotic treatments: the MOZART study. Schizophr Res. (Controlled trial of clozapine [300 mg/day] vs ziprasidone [80-160 mg/day] for 18 weeks; similar efficacy; weight gain +0.8 kg with clozapine vs -2.6 kg with ziprasidone; “no detrimental effects for either drug were observed with regard to ...liver functions…”).
Flanagan RJ. (2008). Fatal toxicity of drugs used in psychiatry. Hum Psychopharmacol. (Deaths from fatal poisonings decreased in England and Wales between 1993-2004, antipsychotic overdose fatalities higher for phenothiazines than atypical antipsychotics; deaths/million prescriptions being 29 for chlorpromazine, 15.5 thioridazine, 3.9 trifluoperazine, 13.3 olanzapine, 21 clozapine, and 31.3 quetiapine).
Keane S, Lane A, Larkin T, Clarke M. (2009). Management of clozapine-related hepatotoxicity. J Clin Psychopharmacol. (Two cases; 52 year old woman developed fatigue and abdominal pain 8 days after starting clozapine [bilirubin normal, ALT 75 rising to 308 U/L, GGT 78 U/L], resolving within 4 weeks of stopping, but she was later able to tolerate long term therapy; 33 year old woman developed abnormal liver tests 5 weeks after starting clozapine [bilirubin normal, ALT 172 U/L, GGT normal], with improvement despite continuing therapy).
Chang A, Krygier DS, Chatur N, Yoshida EM. (2009). Clozapine-induced fatal fulminant hepatic failure: a case report. Can J Gastroenterol. (~40 year old woman with schizophrenia developed nausea and jaundice 6 weeks after starting clozapine which was continued to 8 weeks [bilirubin 18.8 mg/dL, ALT 1668 U/L, Alk P 273 U/L], with progressive hepatic failure and death 4 weeks later).
Chaplin AC, Curley MA, Wanless IR. (2010). Re: Recent case report of clozapine-induced acute hepatic failure. Can J Gastroenterol. (51 year old man developed jaundice 3 months after starting clozapine for schizophrenia [bilirubin 12.7 mg/dL, ALT 526 U/L, Alk P 1079 U/L] who died of cardiac arrest one week after presentation).
Gómez Espín R, Sánchez Quiles I, Hallal H, Plaza J. (2010). Gastroenterol Hepatol. (35 year old man with chronic hepatitis C developed asymptomatic rise in ALT [188 to 723 U/L] and GGT [134 to 648 U/L] 2 months after starting clozapine, improving on stopping and recurring one month after starting olanzapine [ALT 266 to 714 U/L], resolving upon stopping again).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, olanzapine ranked 16th with 62 reports [adjusted reporting odds ratio of 3.1] and clozapine ranked 38th with 36 cases [0.8]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 4 of which were attributed to psychotropic agents [one each due to quetiapine, nefazodone, fluoxetine and venlafaxine], but none were attributed to clozapine or olanzapine).
Kang SH, Lee JI. (2013). Eosinophilia, pleural effusion, hepatitis, and jaundice occurring early in clozapine treatment. Clin Psychopharmacol Neurosci. (47 year old woman with schizophrenia developed eosinophilia at 4 weeks, fever and myalgias at 5 weeks, and jaundice at 8 weeks after starting clozapine [bilirubin 6.0 mg/dL, ALT 254 U/L, GGT 573 U/L, eosinophils 12.9%], resolving rapidly on stopping and not recurring with olanzapine and haloperidol therapy).
Brown CA, Telio S, Warnock CA, Wong AH. (2013). Clozapine toxicity and hepatitis. J Clin Psychopharmacol. (48 year old woman with schizophrenia developed fatigue 4 weeks after starting clozapine [ALT 444 U/L, bilirubin, Alk P and eosinophil counts normal], resolving rapidly on stopping and not recurring on haloperidol).
Tucker P. (2013). Liver toxicity with clozapine. Aust N Z J Psychiatry. (21 year old man with schizophrenia developed fatigue after 3 weeks of clozapine [bilirubin 1.5 rising to 6.5 mg/dL, ALT 794 to 2282 U/L, GGT normal to 164 U/L, with leukocytosis], resolving within 4 weeks of stopping and not recurring on sulpride).
Nielsen J, Correll CU, Manu P, Kane JM. (2013). Termination of clozapine treatment due to medical reasons: when is it warranted and how can it be avoided?. J Clin Psychiatry. (Systematic review of 81 studies of clozapine suggests that discontinuation of clozapine is warranted for ALT or AST elevations beyond 3 times ULN, but that dose lowering and rechallenge is sometimes possible).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to clozapine or olanzapine).
Kane JP, O'Neill FA. (2014). Clozapine-induced liver injury and pleural effusion. Ment Illn. (48 year old woman with schizophrenia developed fatigue and fever [bilirubin 1.4 mg/dL, ALT 894 U/L, Alk P 220 U/L, eosinophils 2390], with worsening of abnormalities until clozapine was stopped, whereupon all tests returned to normal within 6 weeks).
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. (2015). Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol. (Among 76 cases of suspected drug induced liver injury and 377 controls enrolled in a German, prospective hospital-based registry, 5 cases but only 1 control were receiving clozapine [odds ratio=34.6]).
Wu Chou AI, Lu ML, Shen WW. (2014). Hepatotoxicity induced by clozapine: a case report and review of literature. Neuropsychiatr Dis Treat. (45 year old woman with schizophrenia develop fatigue 12 days after switching from olanzapine to clozapine [bilirubin normal, ALT 181 U/L, Alk P not given], resolving within 2 weeks of stopping and recurring [fever and ALT 69 U/L] at a dose of 100 mg daily).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to clozapine or olanzapine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.7%] were attributed to antipsychotic medications, including 3 to quetiapine and 2 to olanzapine, but none to clozapine).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Lally J, Al Kalbani H, Krivoy A, Murphy KC, Gaughran F, MacCabe JH. (2018). Hepatitis, interstitial nephritis, and pancreatitis in association with clozapine treatment: a systematic review of case series and reports. J Clin Psychopharmacol. (A systematic review of the literature identified 42 cases of inflammatory reactions to clozapine, including 20 cases of hepatitis which arose within 8 weeks of starting therapy, half with jaundice, 3 fatal and 2 recurred when “successfully rechallenged”).
Takács A, Sollychin M, Thomas N, Connally F, Pantelis C. (2019). Clozapine rechallenge in a patient with clozapine-induced hepatitis. Australas Psychiatry. (35 year old woman with long standing schizophrenia developed weakness and liver injury within a few months of starting clozapine at age 20, and was tried again on clozapine at age 28 developing abnormal liver tests within 3 days [ALT 136 U/L, Alk P 372 U/L]; was started on a slow titration of clozapine [5 mg daily and increase by 5 mg every 3 days to a final dose of 400 mg daily] at age 31, during which her liver tests remained normal during follow up of 4 years).
de Filippis R, Soldevila-Matías P, De Fazio P, Guinart D, Fuentes-Durá I, Rubio JM, Kane JM, et al. (2020). Clozapine-related drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome: a systematic review. Expert Rev Clin Pharmacol. (Systematic review identified publication of 6 cases of DRESS syndrome associated with clozapine hepatotoxicity, including 3 women, 3 men; ages 27 to 73; latency 8-36 days and one 300 days; all with either fever, rash or both; 2 with lymphadenopathy, 4 with eosinophilia, 4 treated with corticosteroids, all recovered, no deaths, 2 who were rechallenged both had recurrence).
Zarghami M, Hoseini SD, Kazemi A, Elyasi F. (2020). Concurrent hepatotoxicity and neutropenia induced by clozapine. Arch Iran Med. (58 year old man with schizophrenia developed fever and weakness within 7 weeks of starting clozapine [150 mg daily] with neutropenia and hepatitis [bilirubin 11.5 mg/dL, ALT 214 U/L, Alk P 215 U/L, neutrophils 352/µL], resolving within one week of stopping therapy).
Dias CL, Fonseca L, Gadelha A, Noto C. (2021). Clozapine-induced hepatotoxicity: A life threatening situation. Schizophr Res. (Two patients: 33 year old man developed nausea and confusion 12 days after starting clozapine [150 mg] with total bilirubin 1.6 mg/dL and ALT 242 U/L, which fell to normal within a month of stopping and clozapine was later re-introduced without recurrence. 48 year old woman developed nausea and dark urine 20 days after adding clozapine to olanzapine with normal bilirubin, ALT 77 U/L, and Alk P 161 U/L, which returned to normal after stopping clozapine and reintroducing olanzapine).
de Filippis R, Soldevila-Matías P, Guinart D, De Fazio P, Rubio JM, Kane JM, Schoretsanitis G. (2021). Unravelling cases of clozapine-related drug reaction with eosinophilia and systemic symptoms (DRESS) in patients reported otherwise: A systematic review. J Psychopharmacol. (Systematic review identified publication of 27 cases of DRESS syndrome due to clozapine, most commonly with organ involvement of the lung [12 cases: 44%], liver [11 cases: 41%], heart [9 cases: 33%], kidney [9 cases: 33%], gastrointestinal tract, thyroid and bone marrow; 25 with fever, 11 with rash, 13 atypical lymphocytes, 18 eosinophils, 3 fatal, 4 with recurrence upon reexposure, but only 5 identified as DRESS in the original report).
Sernoskie SC, Jee A, Uetrecht JP. (2021). The emerging role of the innate immune response in idiosyncratic drug reactions. Pharmacol Rev. (Review of the role of the innate immune response in drug induced liver disease, uses clozapine as an example).
Revilla-Zúñiga J, Cornejo-Del Carpio J, Cruzado L. Hepatoxicity induced by clozapine: case report and brief review. Rev Colomb Psiquiatr (Engl Ed). 2021:S0034-7450(21)00087-1. English, Spanish. (39 year old woman with schizophrenia developed jaundice 4 weeks after starting clozapine [200 mg daily] [bilirubin 3.5 mg/dL, ALT 268 U/L, eosinophils 40/µL], with persistence of injury and progressive hepatic failure resulting in multiorgan failure and death 6 weeks after presentation).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients).
Ou H, Huang SY. (2022). Corticosteroid therapy for clozapine-induced hepatitis and eosinophilia. Am J Ther. (72 year old woman with schizophrenia developed fever and weakness 4 weeks after starting escalating doses of clozapine [ALT 309 rising to 731 U/L, eosinophils 882 rising to 1907/µL], which improved with stopping clozapine and a short course of corticosteroids, all values being normal 2 months later).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Shah J, Muir J, Furfaro D, Beitler JR, Dzierba AL. (2023). Use of N-acetylcysteine for clozapine-induced acute liver injury: a case report and literature review. J Pharm Pract. (46 year old woman with bipolar disorder and psychosis developed fever and lethargy 1 month after switching from risperidone to clozapine [bilirubin 0.3 rising to 0.7 mg/dL, ALT 364 to 1313 U/L, Alk P 75 to 299 U/L, INR 1.2 to 1.3], who upon worsening was treated with intravenous N-acetylcysteine with subsequent improvement).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury; quetiapine and risperidone as having moderate risk, haloperidol as having low risk, and paliperidone, aripiprazole, lurasidone, and loxapine as having low risk).

## OTHER REFERENCE LINKS

1 Recent References on Clozapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Clozapine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Clozapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clozapine)